# Adefovir

## OVERVIEW

### Introduction

Adefovir dipivoxil is an acyclic nucleotide analogue of adenosine used either alone or in combination with other agents as therapy of chronic hepatitis B. Adefovir does not appear to be a significant cause of drug induced liver injury, but initiation of therapy and sudden withdrawal of therapy can induce a transient exacerbation of the underlying hepatitis B.

### Background

Adefovir dipivoxil (bis-pom PMEA) is an acyclic nucleotide analog and prodrug of adefovir (a def' oh vir). The dipivoxil moiety is hydrolyzed after absorption, and adefovir is phosphorylated intracellularly to its active form, adefovir triphosphate, which competes with deoxyadenosine triphosphate for incorporation into the growing HBV DNA strand, causing inhibition of the viral DNA polymerase and chain termination. Adefovir is indicated for the treatment of chronic hepatitis B as a single agent and with lamivudine for lamivudine-resistant HBV infection. Adefovir was approved by the FDA in 2002 as therapy for hepatitis B. Adefovir is available generically and under the brand name Hepsera in 10 mg tablets. The recommended dose of adefovir is 10 mg orally once daily in adults and children age 12 years and older. The dose should be adjusted for renal impairment. Adefovir has minimal activity against human immunodeficiency virus (HIV) infection and is considered contraindicated in patients with HBV-HIV coinfection. Recently, adefovir has been largely replaced by tenofovir which has a similar mechanism and spectrum of activity, but is approximately 30 times more potent against HBV. Side effects of adefovir include asthenia and renal injury which is marked by increases in serum creatinine levels, hypophosphatemia, hypouricemia and renal tubular acidosis.

### Hepatotoxicity

Serum aminotransferase elevations are common during or after therapy of hepatitis B, but appear to be due to exacerbations of the underlying HBV infection rather than hepatotoxicity. Sudden withdrawal of adefovir therapy can lead to an acute flare of hepatitis as viral levels suddenly rise. These withdrawal flares are usually transient and self-limited, but in rare instances are symptomatic and severe and can lead to death or need for liver transplantation. Instances of moderate serum aminotransferase elevations early during treatment have been described in clinical trials, but these elevations are usually transient and asymptomatic and are found in up to 25% of persons who start nucleoside analogue therapy of hepatitis B. Finally, development of antiviral resistance can be followed by a flare of the underlying hepatitis B as HBV DNA levels rise. Antiviral resistance to adefovir is rare during the first 1 to 2 years of therapy, but increasing rates are found with long-term therapy.

Adefovir has not been associated with cases of lactic acidosis with hepatic steatosis and liver failure. Tenofovir, a nucleotide analogue similar to adefovir, has been associated with isolated cases of lactic acidosis, but only in combination with other antiretroviral agents that are more closely linked to this syndrome. Because adefovir is considered contraindicated in HIV infection (it has weak anti-HIV activity), it is not used in combination with typical antiretroviral drugs. There have been no convincing cases of lactic acidosis or of clinically apparent liver injury with symptoms or jaundice due to adefovir.

Likehood score: E (unlikely cause of clinically apparent, idiosyncratic liver injury).

### Mechanism of Injury

The apparent absence of significant hepatotoxicity from adefovir may be due to its minimal hepatic metabolism and rapid urinary excretion. In vitro, adefovir demonstrates little inhibitory activity against mitochondrial polymerase gamma.

### Outcome and Management

The mild-to-moderate ALT elevations associated with initiating adefovir use are usually asymptomatic and transient. Due to the high percentage of patients who have flares of hepatitis B after discontinuation of adefovir, serum aminotransferase testing should be monitored for several months and antiviral therapy resumed if symptoms or jaundice arise or serum aminotransferases remain significantly above baseline (pretreatment) levels. Patients who develop antiviral resistance to adefovir can have significant flares of hepatitis B and should be switched to or have added another agent with a different profile of resistance.

[Agents used in therapy of HBV infection include adefovir, emtricitabine, entecavir, lamivudine, telbivudine, tenofovir, interferon alfa and peginterferon.]

Drug Class: Antiviral Agents, Antiretroviral Agents, Hepatitis B Agents

Other Drugs in the Subclass, Nucleoside Analogues: Abacavir, Didanosine, Emtricitabine, Entecavir, Lamivudine, Stavudine, Telbivudine, Tenofovir, Zidovudine

## CASE REPORT

### Case 1. Flare of hepatitis B accompanying development of adefovir resistance.

[NIH Case: Adefovir-Lamivudine #6]

A 56 year old man with chronic hepatitis B and previous therapy with interferon and lamivudine was treated with adefovir (10 mg daily). He took no other medications and did not drink alcohol. He had no symptoms of hepatitis, but appeared to have Gilbert’s syndrome with intermittently elevated total bilirubin levels, but normal direct fractions. He was positive for HBsAg and HBeAg in serum and HBV DNA levels were high. Molecular testing revealed evidence of lamivudine-resistant virus (rtM204V/rtL180M). ALT levels were only modestly elevated (Table). A liver biopsy showed moderate histological activity and bridging hepatic fibrosis. With adefovir therapy, serum HBV DNA levels decreased by only 3 to 4 log10 copies per mL and ALT levels improved minimally. Liver histology did not change. He remained asymptomatic and had no other medical problems. During the third year of therapy, HBV DNA levels began to rise towards pretreatment values and serum ALT levels increased five-fold. Molecular testing showed presence of the typical adefovir-resistant mutation in the HBV polymerase gene: rtN236T. Switching therapy to tenofovir led to prompt decrease in HBV DNA levels and improvements in ALT values.

#### Key Points

Medication: | Adefovir (10 mg daily)
Pattern: | Hepatocellular
Severity: | 1+ (aminotransferase elevations without jaundice)
Latency: | 3 years
Recovery: | After switching to tenofovir therapy
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | HBV DNA (copies/mL) | Other
0 | | 55 | 95 | 1.7 | 456,000,000 | Liver biopsy
6 months | | 46 | 105 | 1.6 | 892,000
1 year | | 48 | 90 | 2.7 | 489,000 | Liver biopsy
2 years | | 45 | 108 | 1.7 | 120,000
3 years | | 33 | 114 | 2.2 | 121,506
3.7 years | | 43 | 94 | 1.2 | 132,026,000 | rtN236T mutation
4 years | | 205 | 98 | 1.9 | 31,349,600
Switched to tenofovir therapy (300 mg daily)
2 months* | 2 months | 61 | 108 | 2.5 | 1,715
6months* | 6 months | 27 | 129 | 2.5 | <58
5 years* | 5 years | 25 | 130 | 1.5 | <10
Normal Values | | <42 | <115 | <1.2

*Time after switching to tenofovir

#### Comment

Adefovir therapy of chronic hepatitis B is associated with a low rate of antiviral resistance during the first 1 to 2 years of treatment, but a somewhat high rate of poor initial response (as in this patient). Antiviral resistant rates increase to 17% to 28% after 3 to 4 years of treatment. Development of virological breakthrough is commonly followed by a flare in the underlying hepatitis. In this patient, the flare was mild and the adefovir-resistant virus was successfully suppressed by tenofovir therapy. These features make monotherapy with adefovir problematic in chronic hepatitis B and it is now rarely used.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Adefovir – Hepsera®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=adefovir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Adefovir | 106941-25-7 | C8-H12-N5-O4-P | Adefovir Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 February 2016

Núñez M. Hepatitis treatments. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 511-2. (Review of hepatotoxicity of antiviral agents; mentions the potential of severe flares of disease upon withdrawal of therapy in chronic hepatitis B).
Acosta EP, Flexner C. Antiviral agents (nonretroviral). In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1593-1622. (Textbook of pharmacology and therapeutics).
Gilson RJ, Chopra KB, Newell AM, Murray-Lyon IM, Nelson MR, Rice SJ, Tedder RS, et al. A placebo-controlled phase I/II study of Adefovir dipivoxil in patients with chronic hepatitis B virus infection. J Viral Hepat 1999; 6: 387-95. (Controlled trial of high doses of adefovir [125 mg/day] vs placebo in 20 patients with chronic hepatitis B; ALT elevations of 724 U/L and 980 U/L occurred in 2 patients early during therapy and elevations above 300 U/L in 4 after withdrawal; none developed jaundice). 10607255
Marcellin P, Change TT, Lim SG, Tong MJ, Sievert W, Shiffman ML, Jeffers L, et al.; Adefovir Dipivoxil 437 Study Group. Adefovir dipivoxil for the treatment of hepatitis B e antigen-positive chronic hepatitis B. N Engl J Med 2003; 348: 808-16. (Controlled trial of adefovir vs placebo for 48 weeks in 515 patients with HBeAg-positive chronic hepatitis B: ALT elevations >10 times ULN occurred in 9% of adefovir vs 19% placebo recipients; in the adefovir group, no patient had jaundice or needed to stop therapy for ALT elevations). 12606735
Hadziyannis SJ, Tassopoulos NC, Heathcote EJ, Chang TT, Kitis G, Rizzetto M, Marcellin P, et al.; Adefovir Dipivoxil 438 Study Group. Adefovir dipivoxil for the treatment of hepatitis B e antigen-negative chronic hepatitis B. N Engl J Med 2003; 348: 800-7. Erratum in: N Engl J Med 2003; 348: 1192. (Controlled trial of adefovir vs placebo for 48 weeks in 185 patients with HBeAg-negative chronic hepatitis B; one placebo- but no adefovir-treated patient had severe flare of hepatitis). 12606734
Rivas P, Polo J, de Górgolas M, Fernández-Guerrero ML. Drug Points: Fatal lactic acidosis associated with tenofovir. BMJ 2003, 327: 711. (45 year old woman with HIV-HCV coinfection developed jaundice and lactic acidosis on tenofovir [8 weeks], didanosine and stavudine [long term] [bilirubin 12.6 mg/dL, ALT 157 U/L], with progressive liver failure and death; role of tenofovir vs didanosine and stavudine uncertain). 14512477
Murphy MD, O.Hearn M, Chou S. Fatal lactic acidosis and acute renal failure after addition of tenofovir to an antiretroviral regimen containing didanosine. CID 2003; 36: 1982-6. (49 year old man with HIV and renal insufficiency on long term didanosine developed progressive, fatal lactic acidosis 6 weeks after starting tenofovir; lactate of 5.5 rising to 16.7 mM; no mention of liver injury). 12684925
Guo Y, Fung HB. Fatal lactic acidosis associated with coadministration of didanosine and tenofovir disoproxil fumarate. Pharmacotherapy 2004; 24: 1089-94. (63 year old man with HIV and HCV developed fatal lactic acidosis 1.5 years after starting didanosine-tenofovir-lopinavir-ritonavir regimen, with pancreatitis, multiorgan failure and death; liver injury not mentioned). 15338857
Abrescia N, D'Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. Hepatotoxicity of antiretroviral drugs. Curr Pharm Des 2005; 11: 3697-710. (Review of risk factors, epidemiology and pathogenic mechanisms of hepatotoxicity caused by antiretroviral drugs). 16305505
Masiá M, Gutiérrez F, Padilla S, Ramos JM, Pascual J. Severe toxicity associated with the combination of tenofovir and didanosine: case report and review. Int J STD AIDS 2005; 16: 646-8. (45 year old with HIV-HCV coinfection developed lactic acidosis and "mild cholestasis" 3 months after adding tenofovir to didanosine, resolving slowly after stopping therapy). 16176639
Hadziyannis SJ, Tassopoulos NC, Heathcote EJ, Chang TT, Kitis G, Rizzetto M, Marcellin P, et al.; Adefovir Dipivoxil 438 Study Group. Long-term therapy with adefovir dipivoxil for HBeAg-negative chronic hepatitis B for up to 5 years. Gastroenterology. 2006; 131: 1743-51. (Results after 2 years in 185 HBeAg-negative chronic hepatitis B; 13 of 38 [32%] patients who stopped adefovir after 1 year had rise in ALT >10 times ULN, one with jaundice). 17087951
Schiff E, Lai CL, Hadziyannis S, Neuhaus P, Terrault N, Colombo M, Tillmann H, et al.; Adefovir Dipivoxil Study 45 International Investigators Group. Adefovir dipivoxil for wait-listed and post-liver transplantation patients with lamivudine-resistant hepatitis B: final long-term results. Liver Transpl 2007; 13: 349-60. (Among 226 pre- and 241 post-transplant patients with chronic hepatitis B treated with adefovir for up to 2 years, ALT elevations occurred in 2-4%; none considered serious or requiring drug discontinuation). 17326221
Chan HL, Heathcote EJ, Marcellin P, Lai CL, Cho M, Moon YM, Chao YC, et al.; 018 Study Group. Treatment of hepatitis B e antigen positive chronic hepatitis with telbivudine or adefovir: a randomized trial. Ann Intern Med 2007; 147: 745-54. (Controlled trial of telbivudine vs adefovir in 135 patients with HBeAg-positive chronic hepatitis B, mild transient elevations in ALT occurred in both groups). 17909201
Marcellin P, Chang TT, Lim SG, Sievert W, Tong M, Arterburn S, Borroto-Esoda K, et al. Long-term efficacy and safety of adefovir dipivoxil for the treatment of hepatitis B e antigen-positive chronic hepatitis B. Hepatology 2008; 48: 750-8. (Among 65 patients with HBeAg-positive chronic hepatitis B treated for up to 5 years, 9% had ALT elevation above 5 times ULN, all resolving without change in therapy). 18752330
Marcellin P, Heathcote EJ, Buti M, Gane E, de Man RA, Krastev Z, Germanidis G, et al. Tenofovir disoproxil fumarate versus adefovir dipivoxil for chronic hepatitis B. N Engl J Med 2008; 359: 2442-55. (Two controlled trials of tenofovir vs adefovir in 641 patients with chronic hepatitis B; ALT levels above 5 times ULN occurred in 6% of tenofovir and 3% of adefovir recipients, usually within 8 weeks of starting; all were self-limited even with continuing drug). 19052126
Fontana RJ. Side effects of long-term oral antiviral therapy for hepatitis B. Hepatology 2009; 49 (5 Suppl): S185-95. (Review of side effects of nucleoside analogues used to treat chronic hepatitis B). 19399802
Gara N, Zhao X, Collins MT, Chong WH, Kleiner DE, Liang JT, Ghany MG, et al. Renal tubular dysfunction during long-term adefovir or tenofovir therapy in chronic hepatitis B. Aliment Pharmacol Ther 2012; 35: 1317-25. (Among 51 patients with chronic hepatitis B treated with adefovir or tenofovir for 1 to 10 years, 7 [14%] developed renal tubular dysfunction). 22506503
Ghany MG, Feld JJ, Zhao X, Heller T, Doo E, Rotman Y, Nagabhyru P, et al. Randomised clinical trial: the benefit of combination therapy with adefovir and lamivudine for chronic hepatitis B. Aliment Pharmacol Ther 2012 Mar 26. [Epub ahead of print] (Controlled trial of adefovir alone vs its combination with lamivudine in 41 patients with chronic hepatitis B treated for up to 4 years demonstated a better long term response rate with the combination; no hepatotoxicity mentioned). 22449251
Antiviral drugs. Treat Guidel Med Lett 2013; 11 (127): 19-30. (Review of safety and efficacy of antivirals used to treated hepatitis B mentions that acute flares of hepatitis B occur in up to 25% of patients who discontinue adefovir). 23459414
Terrault NA, Bzowej NH, Chang KM, Hwang JP, Jonas MM, Murad MH. AASLD guidelines for treatment of chronic hepatitis B. Hepatology 2016; 63: 261-83. (Guidelines for management and treatment of hepatitis B from the American Association for the Study of Liver Diseases lists adefovir as an approved oral therapy of chronic hepatitis B). 26566064

## OTHER REFERENCE LINKS

1. Recent References on Adefovir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Adefovir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Adefovir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Adefovir)